# Ibalizumab

## OVERVIEW

### Introduction

Ibalizumab is a humanized monoclonal antibody to CD4, the cell surface receptor for the HIV-1 envelope glycoprotein (gp120), which is used to treat patients with multidrug resistant HIV-1 infection. Ibalizumab therapy has not been associated with serum enzyme elevations or to instances of clinically apparent drug induced liver injury.

### Background

Ibalizumab (eye' ba liz' ue mab) is a recombinant humanized monoclonal antibody to CD4, the cell surface receptor for the HIV-1 envelope glycoprotein 120 (gp120). Ibalizumab does not block the binding of gp120 to CD4 but rather inhibits the conformation changes in the CD4/gp120 complex that allows binding to a second cellular receptor, chemokine-receptor-4 (CXCR4), thus inhibiting HIV replication. Clinical trials of ibalizumab in heavily treatment-experienced HIV-positive patients with multidrug resistance have shown that it decreased HIV RNA levels and resulted in full suppression in over half of patients. Ibalizumab was approved for use in the United States in 2018 for therapy (in combination with other antiretroviral agents) of patients with multidrug resistant HIV-1 infection. Ibalizumab is available in solution in single dose vials of 200 mg/1.33 mL under the brand name Trogarzo. Ibalizumab is administered as an intravenous infusion. The recommended dose is an initial loading dose of 2,000 mg followed by a maintenance dose of 800 mg every 2 weeks. Side effects are generally mild and include injection site reactions, diarrhea, dizziness, nausea and rash. Rare but potentially severe adverse events include hypersensitivity reactions and immune reconstitution syndrome.

### Hepatotoxicity

The prelicensure clinical trials of ibalizumab included a limited number of patients, many of whom had other serious comorbidities including cirrhosis and chronic hepatitis B and C. In these trials, serum aminotransferase elevations occurred in 14% to 25% of patients, but the abnormalities were generally mild and self-limited and often attributable to other underlying conditions. Serum bilirubin levels were elevated above 2.5 mg/dL in 5% of patients, but no patient developed both serum aminotransferase and bilirubin elevations or clinically apparent liver injury. There were no serious hepatic adverse events or deaths that were attributed to ibalizumab therapy. Since approval, there have been no published reports of clinically apparent acute liver injury attributed to ibalizumab, but it has had limited general use.

Likelihood score: E (unlikely cause of clinically apparent liver injury, but data on safety are limited).

### Mechanism of Liver Injury

Ibalizumab is a human monoclonal antibody and is unlikely to be inherently hepatotoxic. Recombinant proteins are often metabolized in the cells on which they act but are also metabolized in the liver, largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic. Ibalizumab therapy does not appear to affect other CD4 receptor functions.

Drug Class: Antiviral Agents; Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ibalizumab – Trogarzo®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ibalizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ibalizumab | 680188-33-4 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 08 August 2018

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents written before the availability of ibalizumab; "the biological immuno-suppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists”).
Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents, written before the availability of ibalizumab).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1623-64. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
http://aidsinfo.nih.gov/guidelines. (Regularly updated clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Ibalizumab-uiyk (Trogarzo) for multidrug-resistant HIV. Med Lett Drugs Ther 2018; 60 (1545): 68-9. (Concise review of the mechanism of action, clinical efficacy, safety and costs of ibalizumab shortly after its approval in the US; mentions that diarrhea, dizziness, nausea and rash occurred in 5-8% of treated patients and that laboratory abnormalities included increases in serum bilirubin, but does not mention ALT elevations or hepatotoxicity). 29667947
Bruno CJ, Jacobson JM. Ibalizumab: an anti-CD4 monoclonal antibody for the treatment of HIV-1 infection. J Antimicrob Chemother 2010; 65: 1839-41. (Summary of the structure, mechanism of action and results of early human trials of ibalizumab in patients with refractory HIV infection; states that it was “well tolerated”; no mention of ALT elevations or hepatotoxicity). 20639524
Emu B, Fessel J, Schrader S, Kumar P, Richmond G, Win S, Weinheimer S, et al. Phase 3 study of ibalizumab for multidrug-resistant HIV-1. N Engl J Med 2018; 379: 645-54. (Among 40 patients with multidrug resistant HIV infection treated with infusions of ibalizumab, 83% had a decrease in HIV RNA levels, and adverse events were common, the most frequent being diarrhea but no patient developed hepatotoxicity). 30110589
Markham A. Ibalizumab: first global approval. Drugs. 2018; 78 (7): 781-5. (Summary of the development, pharmacology, results of clinical trials and adverse events of ibalizumab; mentions that only two severe adverse events were reported, a severe rash and a case of immune reconstitution syndrome). 29675744

## OTHER REFERENCE LINKS

1. Recent References on Ibalizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(theophylline/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ibalizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=theophylline)